# Nitrofurantoin

## OVERVIEW

### Introduction

Nitrofurantoin is an oral antibiotic widely used either short term to treat acute urinary tract infections or long term as chronic prophylaxis against recurrent infections. Nitrofurantoin is one of the most common causes of drug induced liver disease and can cause either an acute or a chronic hepatitis-like syndrome that can be severe and lead to cirrhosis and liver failure.

### Background

Structurally, nitrofurantoin (nye" troe fure an' toyn) is a nitrated 5-member furan ring with a side chain of hydantoin. Nitrofurantoin inhibits several bacterial enzyme systems and has broad antibacterial activity. Its precise mechanism of action is not known. Importantly, antibacterial resistance to nitrofurantoin is rare, which makes it an attractive choice for long term treatment. In addition, nitrofurantoin is well absorbed orally and is rapidly excreted in the urine so that drug levels in urine are high while serum levels are minimal, which makes it an appropriate agent to treat urinary tract but not systemic infections. Nitrofurantoin was first approved for use in the United States in 1953 and is still in wide use with more than 3 million prescriptions filled yearly. Current indications are treatment of acute and prophylaxis against chronic or recurrent urinary tract infections due to susceptible organisms. For treatment of acute infections, the recommended regimen is 50 to 100 mg orally four times daily for one week. For prophylaxis against chronic or recurrent infections, the recommended dose is 50 to 100 mg daily long term. Generic formulations are available (25, 50, and 100 mg); specific commercial names include Macrodantin, Macrobid and Furadantin, among others. Common side effects include nausea, diarrhea, dyspepsia, dizziness, drowsiness and rash. Nitrofurantoin has multiple rare, but potentially severe side effects that arise particularly with long term use and include interstitial pneumonitis, peripheral neuropathy, exfoliative dermatitis, hemolytic anemia, lupus-like syndromes and hepatotoxicity.

### Hepatotoxicity

Nitrofurantoin is currently one of the most common causes of drug induced liver injury. Liver injury from nitrofurantoin can cause either an acute or chronic hepatitis-like syndrome. The acute form is typically associated with a 1 or 2 week course of treatment with nitrofurantoin and is rare (~0.3 cases per 100,000 prescriptions). Acute liver injury typically presents within a few weeks of starting nitrofurantoin and can arise up to a few weeks after stopping a defined course of treatment. The pattern of liver injury is usually hepatocellular with or without jaundice, and typically is accompanied by symptoms of fever and rash. The acute injury due to nitrofurantoin usually resolves rapidly once the medication is stopped, but severe and fatal instances have been reported. In some instances, autoimmune features are present, but these are more common with the chronic presentation of nitrofurantoin hepatotoxicity. The course and outcome of acute nitrofurantoin hepatotoxicity is variable, severe forms with acute liver failure can occur, and nitrofurantoin is regularly listed as one of the major causes of acute liver failure due to medications.

The chronic form of nitrofurantoin hepatotoxicity is more common than the acute form and typically presents months to years after initiation of long term prophylactic therapy. The estimated incidence of liver injury from nitrofurantoin typically ranges between 1 per 1,500 and 1 per 3,000 persons exposed. The presentation is usually insidious, initially accompanied by fatigue and weakness followed by dark urine and jaundice. The clinical pattern and laboratory features can mimic autoimmune hepatitis with marked elevations in serum ALT levels, increases in gamma globulin levels, and the presence of antinuclear and anti-smooth muscle antibodies. In some instances, the onset is abrupt and resembles acute hepatitis. However, immunoallergic features of fever and rash are less common than with the acute form of nitrofurantoin hepatotoxicity. Liver histology typically demonstrates features of chronic hepatitis with inflammation, interface hepatitis, focal or centrilobular bridging necrosis, and variable degrees of fibrosis. Cirrhosis as a result of nitrofurantoin hepatotoxicity has been reported and, if not recognized as due to the medication, can progress to end stage liver disease. There is a female preponderance and the risk of injury appears to increase with age particularly the chronic forms.

Likelihood score: A (well-known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of nitrofurantoin hepatotoxicity is not known. Its nitro-reductive metabolism produces injurious oxidative free radicals which might damage hepatocytes. Many cases demonstrate evidence an autoimmune etiology. Analyses of HLA-allele associations have yielded varying results including linkage to HLA-DRB1*11:04, DRB1*15:10 or *16:01, DRB1*03:01 or *04:01, DQB1*02:02, and A*33:01. None of these allele associations were strong enough to be useful clinically, usually being found in less than 30% of cases.

### Outcome and Management

The severity of nitrofurantoin induced liver injury ranges from mildly symptomatic elevations in serum aminotransferase levels (Cases 1 and 2), hepatitis with jaundice (Case 3) to fulminant liver failure and death (Case 4). Complete recovery is expected after stopping the drug, but recovery may be slow (2 to 6 months). In rare instances, evidence of chronic liver injury persists. Because of the autoimmune features of many cases of nitrofurantoin hepatotoxicity, corticosteroids are often used particularly in cases that are severe or slow to resolve. In many instances, corticosteroid therapy appears to lead to improvement. However, the ultimate benefit of immunosuppressive therapy remains to be proven and corticosteroids should be used cautiously and withdrawn as soon as possible, and with careful follow up to document lack of relapse after stopping. Rechallenge leads to recurrence and should be avoided. There does not appear to be cross reactivity to hepatic injury between nitrofurantoin and other commonly used antibiotics.

Drug Class: Antiinfective Agents

## CASE REPORT

### Case 1. Chronic hepatitis with hepatocellular pattern of serum enzyme elevations due to nitrofurantoin.(1)

A 68 year old woman was given nitrofurantoin (50 mg daily) for prophylaxis against recurrent urinary tract infections. She continued on therapy for 3 years at which time serum enzymes were found to be elevated. She had no symptoms that could be attributed to liver disease. Nitrofurantoin was stopped, but restarted one month later because of recurrence of urinary tract infections. Serum aminotransferase levels remained mildly elevated (2 to 3 times the upper limit of normal). Six months later she had the insidious onset of nausea, fatigue and weakness. Serum aminotransferase levels were still elevated, but alkaline phosphatase and bilirubin values were normal. Anti-smooth muscle antibody was present (1:80), but other autoantibodies were not detected. Tests for hepatitis A, B and C were negative. A liver biopsy showed chronic active hepatitis with moderate to severe inflammatory infiltrates and moderate fibrosis. The symptoms persisted for several months and the medication was discontinued again. Two months after stopping nitrofurantoin the patient had returned to her usual state of health and serum aminotransferase levels returned to normal.

#### Key Points

Medication: | Nitrofurantoin, 50 mg daily
Pattern: | Hepatocellular (aminotransferase elevations only)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | Several years, 6 months after restarting
Recovery: | Complete within 5 months
Other medications: | Sumatriptan, alendronate, clopidogrel, estrogen, verapamil

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Nitrofurantoin started
1 month | | 79 | 62 | 0.4
3 months | | 115
4 months | | 88 | | | Nausea, fatigue
5 months | | 255 | | | Liver biopsy
6 months | 0 | 176 | 99 | 0.5 | SMA 1:80
Nitrofurantoin stopped
9 months | 3 months | 52 | 101 | 0.7
11 months | 5 months | 30 | 102 | 0.7
Normal Values | | <42 | <115 | <1.2

#### Comment

Initially, the liver injury was believed to be caused by chronic hepatitis unrelated to medications. Because of appearance of symptoms and findings on liver biopsy, nitrofurantoin was subsequently suspected and discontinued. The resolution of liver test abnormalities and symptoms of fatigue after stopping nitrofurantoin supported the diagnosis of drug induced liver disease. While the clinical pattern resembles idiopathic chronic autoimmune hepatitis, the disease generally resolves once the medication is stopped with or without corticosteroid therapy. In any case, long term follow up to document resolution of hepatitis is warranted, particularly if corticosteroids were used initially.

### Case 2. Mild chronic hepatitis with hepatocellular pattern of enzyme elevations.(1)

A 76 year old woman with a history of recurrent bladder and kidney infections was treated with nitrofurantoin 100 mg daily. After a year, the dose was reduced to 50 mg daily because of serum aminotransferase elevations (Table). One month later, she complained of fatigue and a 10 lb. weight loss. Her serum ALT levels were markedly elevated, but alkaline phosphatase and bilirubin levels were normal. Antinuclear antibody was present (1:80) and globulin levels were mildly elevated. Tests for hepatitis A, B and C were negative. Liver ultrasound was normal. A liver biopsy showed chronic hepatitis, with mild activity and slight fibrosis. This patient had rapid clinical and biochemical improvement once nitrofurantoin was stopped.

#### Key Points

Medication: | Nitrofurantoin
Pattern: | Hepatocellular (R=29)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | 1 year
Recovery: | 6 weeks after stopping
Other medications: | Amlodipine, enalapril, simvastatin, ezetimibe

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 19 | 64 | 1.1
Nitrofurantoin started
11 months | | 66 | 90 | 0.2
12 months | | 83
13 months | | 154 | | | 10 lb. weight loss
13.5 months | | 741
14 months | 0 | 1478 | 131 | 1.4
Nitrofurantoin stopped
15 months | 3 weeks | 292 | 81 | 0.6 | Liver biopsy
17 months | 3 months | 35 | 67 | 0.3
Normal Values | | <42 | <115 | <1.2

#### Comment

The prolonged incubation period to onset of liver injury due to nitrofurantoin frequently leads to mistaken or delayed diagnosis. The clinical pattern is more similar to chronic than acute hepatitis and recovery may be delayed. The current case is very typical and the patient was fortunate to have therapy stopped before the onset of jaundice. The injury is frequently accompanied by autoantibodies (ANA or SMA) which may persist after withdrawal of nitrofurantoin, but generally in low titer.

### Case 3. Severe chronic active hepatitis with autoimmune features and pseudotumor due to nitrofurantoin hepatotoxicity.(1)

An 84 year old woman was treated with nitrofurantoin 50 mg once daily for seven months. Because of recurrence of urinary tract infections, it was restarted one year later. After another 14 months of taking nitrofurantoin, she was found to have jaundice and peripheral edema. She was hospitalized for investigation. Serum aminotransferase, alkaline phosphatase, and bilirubin levels were elevated (Table). MRI suggested an infiltrating tumor in the liver, but endoscopic retrograde cholangio-pancreatography was unrevealing and biopsy of the mass showed no evidence of tumor, but rather chronic inflammation and submassive hepatic necrosis. Tests for hepatitis A, B and C were negative. Antinuclear antibody and smooth muscle antibody titers were strongly positive. Symptoms of abnormal liver tests improved slowly after nitrofurantoin was stopped. At follow up 7 months later, the patient was asymptomatic, and liver enzyme levels were in reference range.

#### Key Points

Medication: | Nitrofurantoin
Pattern: | Chronic hepatitis, cholestatic pattern of enzymes (R=1.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Three years after starting (intermittent use)
Recovery: | Protracted but complete
Other medications: | Losartan, warfarin, atorvastatin, diltiazem

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Nitrofurantoin started
8 months | | Nitrofurantoin stopped
Pre-Restarting | | 16
Nitrofurantoin restarted
7 months | | 52
9 months | | 115
10 months | | 127 | 109 | 0.9
12 months | | 190 | 175 | 1.5
13 months | | 197 | 359 | 3.8 | Edema
14 months | 0 | 307 | 503 | 5 | Jaundice
Nitrofurantoin stopped again
15 months | 1 month | 89 | 301 | 5.8 | Albumin 2.6, ANA 1:320
17 months | 3 months | 45 | 145 | 1.1
21 months | 7 months | 39 | | 0.9 | Albumin 3.7
Normal Values | | <42 | <130 | <1.2

#### Comment

This elderly lady presented with a clinical picture suggestive of liver cancer after more than a year of intermittent therapy with nitrofurantoin. A liver biopsy demonstrated a histologic picture of severe chronic active hepatitis. Autoimmune markers were present. The resolution of the injury after withdrawal of drug supports the diagnosis of a drug induced chronic hepatitis with autoimmune features.

### Case 4. Acute liver failure due to nitrofurantoin.(1)

A 46 year old woman with history of spina bifida and neurogenic bladder was treated with nitrofurantoin in a dose of 50 mg per day for recurrent urinary tract infections. Therapy was effective in suppressing infections and she remained on the drug for 3 and a half years, when she was found to have jaundice, followed shortly thereafter by fatigue, nausea and vomiting. She was hospitalized for investigation. Serum aminotransferase and bilirubin levels were markedly elevated. Tests for hepatitis A, B and C were negative. Anti-nuclear and anti-smooth muscle antibody titers were elevated. CT of the abdomen showed no evidence of biliary obstruction or hepatic masses. Because of worsening hepatic failure, she was transferred to a liver transplant center, but she rapidly developed mental obtundation, coma and respiratory failure, followed by intractable cerebral edema and death five days later. Autopsy showed a small, shrunken liver weighing ~600 g.

#### Key Points

Medication: | Nitrofurantoin
Pattern: | Hepatocellular (R=16)
Severity: | 5+ (death)
Latency: | 3.5 years
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | Pre | 23 | 152 | 0.7
0 | | Nitrofurantoin started
3.5 years | | Jaundice, fatigue, nausea
| -2 days | 1988 | 338 | 28.9 | Hospitalized: INR = 4.0
| -1 day | 1676 | 296 | 27.7 | INR = 5.0
| 0 | Nitrofurantoin stopped
3.5 years | 1 day | 1525 | 285 | 31.5 | INR = 6.0
| 2 days | 1325 | 260 | 26.6 | INR = 11.0
| 3 days | 907 | 150 | 27.3 | Transferred
| 4 days | 538 | 134 | 28 | Respiratory failure,
| 5 days | 491 | 184 | 28.4 | Cerebral edema, Death
Normal Values | | <42 | <115 | <1.2

#### Comment

The clinical pattern indicated an acute hepatitis-like picture, but the timing and gradual onset was more representative of chronic hepatitis with a severe unrelenting course. Nevertheless, autopsy revealed massive hepatic necrosis suggesting an acute process. In hepatocellular forms of drug induced liver disease, jaundice indicates severe injury with a mortality rate that is greater than 10%, a finding stressed by the late Dr. Hyman J. Zimmerman and familiarly known as “Hy’s law”.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nitrofurantoin – Generic (Various), Furadantin®, Macrodantin®

DRUG CLASS

Antiinfective Agents, Urinary (Nitrofuran Derivative)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nitrofurantoin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nitrofurantoin | 67-20-9 17140-81-7 (Monohydrate) 54-87-5 (Sodium) | C8-H6-N4-O5; C8-H6-N4-O5.H2-O; C8-H6-N4-O5.Na

## CITED REFERENCE

1 de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, et al; Drug-Induced Liver Injury Network. Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol 2017; 15: 103-112.e2.27311619

## ANNOTATED BIBLIOGRAPHY

References updated: 20 June 2025

Abbreviations: SMA, smooth muscle antibody; ANA, antinuclear antibody.

Zimmerman HJ. Nitrofurantoin. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 603-5. (Expert review of nitrofurantoin hepatotoxicity published in 1999; while there were no reports of liver injury during the first decade of its use, nitrofurantoin later became a frequent cause of hepatotoxicity presenting either acutely with cholestatic or hepatocellular jaundice or chronically with a chronic hepatitis-like syndrome with latency varying from 1 month to many years, typically with autoimmune features and sometimes with granulomas).
Moseley RH. Nitrofurantoin. Hepatotoxicity of antimicrobial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 469-70. (Expert review of nitrofurantoin induced liver injury mentions that a wide variety of forms of injury have been described including cholestatic hepatitis, hepatocellular injury, granulomatous hepatitis, chronic hepatitis and cirrhosis; clinical features often resemble autoimmune hepatitis and incidence increases with age and is higher in women).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-21. (Textbook of pharmacology and therapeutics).
Ernaelsteen D, Williams R. Jaundice due to nitrofurantoin. Gastroenterology 1961; 41: 590-3. (54 year old woman who had developed fever, rash and malaise 5 days after starting a second course of nitrofurantoin, redeveloped fever and rash one day after starting a third course [bilirubin 2.1 rising to 6.1 mg/dL, ALT 72 U/L, Alk P 3.5 times ULN, eosinophils 1,600], resolving within 6 weeks of stopping).
Cook GC, Sherlock S. Jaundice and its relation to therapeutic agents. Lancet 1965; 1 (7378): 175-9. (Among 20 cases of drug induced cholestatic jaundice, 18 had taken phenothiazines and 1 nitrofurantoin, a 54 year old woman who developed jaundice within 8 days of starting nitrofurantoin [bilirubin 2.0 mg/dL, Alk P 3.5 times ULN], resolving within 50 days; probably same case as in Ernaelsteen [1961]). 14238042
Jokela S. Liver disease due to nitrofurantoin. Gastroenterology 1967; 53: 306-11. (41 year old woman developed nausea within 2 weeks of starting nitrofurantoin [bilirubin 13 mg/dL, ALT 380 U/L, Alk P 2 times ULN, 5% eosinophils], resolving within 1 month on corticosteroids, redeveloping jaundice [bilirubin 13 mg/dL, ALT 900, Alk P 3 times ULN] within 2 weeks of restarting).
Jowers LV, Shannon SR. Jaundice due to nitrofurantoin. J S C Med Assoc 1967; 63: 357-8.5234064
Wasowska T, Krus S. Jaundice induced by furadantin treatment: case description. Pol Med J 1968; 7: 322-7. (50 year old woman developed fever, jaundice, acidosis and coma 10 days after starting a second course of nitrofurantoin [bilirubin 16 mg/dL, ALT 22 U/L, Alk P 2 times ULN, prothrombin index 68%], jaundice improving, but patient dying 11 days later of renal failure due to pyelonephritis). 5658046
Murphy KJ, Innis MD. Hepatic disorder and severe bleeding diathesis following nitrofurantoin ingestion. JAMA 1968; 204: 396-7. (65 year old man developed excessive bleeding [protime 58 sec] 1 month after starting nitrofurantoin [bilirubin 0.9 rising to 5.4 mg/dL, ALT not provided, Alk P 2.5 times ULN] requiring plasma infusions, ICU care and tracheostomy, but resolving within 2 weeks of stopping). 5694455
Bhagwat AG, Warren RE. Hepatic reaction to nitrofurantoin. Lancet 1969; 2 (7634): 1369. (57 year old woman developed rash and arthralgias 2 weeks after starting nitrofurantoin [bilirubin 0.5 mg/dL, AST 98 U/L, Alk P 3 times ULN], resolving within 7 days of stopping). 4188135
Sotaniemi E, Hokkanen O, Kaipainen WJ. Hepatic injury and multiple drug treatment. Ann Clin Res 1971; 3: 220-5. (Among 55 patients admitted for drug induced liver injury to one hospital in Finland during a 5 year period [0.3% of total admissions], the most commonly implicated agents were sulfonamides [n=23], nitrofurantoin [11: 20%], oral contraceptives [11], hydralazine [8], and chloramphenicol [6]; 39 [79%] were taking more than one agent). 5093153
Lamberger B, von Schenck H. [Nitrofurantoin induced icterus] Lakartidningen 1973; 70: 2655. Swedish. (48 year old woman developed jaundice 4 years after starting daily nitrofurantoin [bilirubin 17 mg/dL, ALT 1275 U/L, GGT 4 times ULN], resolving upon stopping and recurring twice 2 weeks [bilirubin normal and ALT 825 U/L] and then 1 week after restarting [bilirubin 3.2 mg/dL and ALT 1225 U/L]). 4787340
Goldstein LI, Ishak KG, Burns W. Hepatic injury associated with nitrofurantoin therapy. Am J Dig Dis 1974; 19: 987-98. (Two cases: 44 year old man developed liver test abnormalities 5 months after starting nitrofurantoin [bilirubin 2.5 mg/dL, ALT 100 U/L, Alk P 35 U/L], resolving within 2 weeks of stopping and recurring within days of restarting; 50 year old woman developed rash, fever and arthralgias within a week of starting nitrofurantoin [bilirubin normal, ALT 100 U/L, Alk P normal], resolving within 2 months). 4424634
Selroos O, Edgren J. Lupus-like syndrome associated with pulmonary reaction to nitrofurantoin. Report of three cases. Acta Med Scand 1975; 197: 125-9. (Three patients who developed pulmonary toxicity and a lupus-like syndrome 12-38 months after starting nitrofurantoin included a 73 year old woman with liver injury [bilirubin normal, ALT 76 U/L, Alk P 9 times ULN, ANA positive] and biopsy showing chronic active hepatitis, whose liver test abnormalities resolved within 4 months of stopping and whose repeat liver biopsy was normal). 1079107
Klemola H, Penttilä O, Runeberg L, Tallqvist G. Anicteric liver damage during nitrofurantoin medication. Scand J Gastroenterol 1975; 10: 501-5. (Four women, ages 60 to 85 years, developed symptoms and liver test abnormalities without jaundice 10 weeks to 1.5 years after starting nitrofurantoin [ALT 161, 93, 69 and 466 U/L], with hyperglobulinemia and liver biopsy showing chronic hepatitis [3 with cirrhosis], but rapid resolution [2-6 weeks] upon stopping nitrofurantoin). 1153946
Engel JJ, Vogt TR, Wilson DE. Cholestatic hepatitis after administration of furan derivatives. Arch Intern Med 1975; 135: 733-5. (42 year old woman developed fever, rash and nausea 5 days after starting nitrofurantoin [bilirubin 3.4 mg/dL, ALT 256 U/L, Alk P 350 U/L, atypical lymphocytosis], with recurrence of enzyme elevations within a week of starting furazolidone [a furan structurally related to nitrofurantoin] suppositories for vaginitis). 150825
Fagrell B, Strandberg I, Wengle B. A nitrofurantoin-induced disorder simulating chronic active hepatitis. A case report. Acta Med Scand 1976; 199: 237-9. (78 year old woman developed abdominal pain and anorexia 12 months after starting daily nitrofurantoin [peak bilirubin 7.8 mg/dL, AST 930 U/L, ANA >1:1600], resolving within 2 months of stopping, but ANA still weakly positive one year later [1:25]). 1258704
Strömberg A, Wengle B. Letter: Chronic active hepatitis induced by nitrofurantoin. Br Med J 1976; 2 (6028): 174-5. (Among 23 patients diagnosed with chronic active hepatitis between 1969-74, 8 appeared to have drug induced disease, 3 from oxyphenisatin, 1 dihydralazine, 1 sulfonamide, and 3 nitrofurantoin, all resolving with drug discontinuation). 1276848
Strohscheer H, Wegener HH. [Nitrofurantoin-induced granulomatous hepatitis]. MMW Munch Med Wochenschr 1977; 119: 1535-6. German. (Two women, ages 59 and 58 years, developed fever within days of starting nitrofurantoin with minimal ALT elevations and liver biopsies showing granulomas; the fever resolved once nitrofurantoin was stopped). 414090
Mullick FG, Drake RM, Irey NS. Morphologic changes in adverse drug reactions in infants and children. Hum Pathol 1977; 8: 361-78. (Review of pathology of adverse drug reactions in children, including 5 month old boy who developed rash 3 days after starting nitrofurantoin who then became jaundiced [bilirubin 10.6 mg/dL, ALT 1260 U/L] and died of liver failure a few weeks later; autopsy showed massive hepatic necrosis). 302237
Lindberg J, Lindholm A, Iwarson S. Genetic factors in the development of chronic active hepatitis. Lancet 1977; 1 (8002): 67-8. (HLA B8 and or B12 was present in 14 of 16 [88%] cases of cryptogenic autoimmune hepatitis, but in only 12 of 25 [48%] cases of viral or drug induced chronic active hepatitis, 2 being due to nitrofurantoin). 63711
Maddrey WC, Boitnott JK. Drug-induced chronic liver disease. Gastroenterology 1977; 72: 1348-53. (Review of drugs that cause chronic hepatitis including oxyphenisatin, isoniazid, methyldopa, and phenothiazines; nitrofurantoin mentioned as a cause in 4 published cases, all with complete recovery on stopping the drug, but several with cirrhosis). 323097
Rotermund HM. [Drug-induced chronic aggressive hepatitis]. Med Klin 1977; 72: 2139-45. German . (Review of clinical and diagnostic features of drug induced chronic active hepatitis, common causes being oxyphenisatin and methyldopa and rare ones isoniazid, halothane, salicylates and sulfonamides). 593197
Hokkanen OT, Sotaniemi EA. Liver injury and multiple drug therapy. Arch Toxicol Suppl 1978; (1): 173-6. (Among 100 patients admitted for drug induced liver injury to one hospital in Finland during a 10 year period, the most commonly implicated agents were sulfonamides [n=36], oral contraceptives [20], nitrofurantoin [16: 16%], methyldopa [10], hydralazine [8], and chlorpromazine [6]; 74% were taking more than one agent). 277098
Hatoff DE, Cohen M, Schweigert BF, Talbert WM. Nitrofurantoin: another cause of drug-induced chronic active hepatitis? A report of a patient with HLA-B8 antigen. Am J Med 1979; 67:117-21. (27 year old woman developed fatigue and abdominal pain with AST elevations [~210 U/L] which remained elevated until nitrofurantoin was stopped 6 months later, biopsy showed cirrhosis; she was later reexposed and developed fever and AST elevation [~700 U/L], which resolved on prednisone therapy). 463905
Iwarson S, Lindberg J, Lundin P. Nitrofurantoin-induced chronic liver disease. Clinical course and outcome of five cases. Scand J Gastroenterol 1979; 14 (4): 497-502. (Five women, ages 45 to 64 years, developed chronic hepatitis 1-3 years after starting daily nitrofurantoin therapy [ALT 588, 576, 390, 420 and 384 U/L, ANA 1:25 to 1:400, IgG 1.7-2.1 g/dL], resolving completely on stopping, but cirrhosis in follow up in one patient). 482863
Gleckman R, Alvarez S, Joubert DW. Drug therapy reviews: nitrofurantoin. Am J Hosp Pharm 1979; 36: 342-51. (Nitrofurantoin is bactericidal and has a low rate of bacterial resistance, but minimal serum levels are achieved as it is rapidly excreted in the urine which results in excellent urinary concentrations that is the basis of its use in urinary tract and bladder infections; hepatotoxicity is not dose related and can be severe with a multitude of clinical presentations including chronic active hepatitis). 369367
Wright R. Drug-induced chronic hepatitis. Springer Semin Immunopathol 1980; 3: 331-8. (Review of drug induced chronic hepatitis focusing upon nitrofurantoin and methyldopa). 7022714
Holmberg L, Boman G, Böttiger LE, Eriksson B, Spross R, Wessling A. Adverse reactions to nitrofurantoin. Analysis of 921 reports. Am J Med 1980; 69: 733-8. (Between 1966 and 1976, 921 adverse events due to nitrofurantoin were reported to a Swedish registry; 50 [6%] of which were hepatic, including 1 fatality due to cirrhosis; mean age 59 years, 86% women, half with latency <1 month, but some with latency >1 year). 7435512
Black M, Rabin L, Schatz N. Nitrofurantoin-induced chronic active hepatitis. Ann Intern Med 1980; 92: 62-4. (Two cases: 48 year old woman developed fatigue 18 months after starting daily nitrofurantoin [bilirubin 1.3 mg/dL, ALT 209 U/L, Alk P 85 U/L, ANA >1: 1280], resolving within 2 months of stopping, but with persistence of ANA; 59 year old woman developed fatigue 2 years after starting daily nitrofurantoin [bilirubin 4.2 mg/dL, ALT 1328 U/L, Alk P 242 U/L, ANA >1:1280], resolving within 3-6 months of stopping, but with persistence of ANA). 7350873
Sharp JR, Ishak KG, Zimmerman HJ. Chronic active hepatitis and severe hepatic necrosis associated with nitrofurantoin. Ann Intern Med 1980; 92: 14-9. (5 women with chronic hepatitis due to nitrofurantoin, arising 1 month to 3 years after starting therapy [bilirubin 5.9-44 mg/dL, AST 435-1000 U/L, ANA positive in 2 of 3 tested], biopsies showing chronic active hepatitis with variable degrees of fibrosis, 2 died; review of literature found 20 cases, all in women, usually arising after 6 months, few with fever or rash, some with cirrhosis, slow resolution). 7350868
Tolman KG. Nitrofurantoin and chronic active hepatitis. Ann Intern Med 1980; 92: 119-20. (Editorial accompanying articles by Black [1980] and Sharp [1980] discussing nitrofurantoin induced chronic hepatitis and its pathogenesis). 7350855
Sippel PJ, Agger WA. Nitrofurantoin-induced granulomatous hepatitis. Urology 1981; 18: 177-8. (49 year old woman developed fever and fatigue 1 month after starting nitrofurantoin [bilirubin not given, ALT 100 U/L, Alk P 255 U/L], with biopsy showing "granulomatous hepatitis", resolving within 4 months of stopping). 7269024
Spoelstra P, Janssens AR, Ruiter DJ, de Vries RR. [Chronic active hepatitis caused by nitrofurantoin]. Ned Tijdschr Geneeskd 1981; 125: 61-3. Dutch. (72 year old woman developed hepatitis several years after starting nitrofurantoin [bilirubin 10.8 mg/dL, ALT 177 U/L, Alk P 382 U/L, ANA positive], biopsy suggesting chronic hepatitis, but resolving within several months of stopping). 7464961
Anttinen H, Ahonen A, Leinonen A, Kallioinen M, Heikkinen ES. Diagnostic imaging of focal nodular hyperplasia of the liver developing during nitrofurantoin therapy. Acta Med Scand 1982; 211: 227-32. (6 year old girl found to have focal nodular hyperplasia 7 months after starting daily nitrofurantoin therapy; all liver tests were normal and the lesion was successfully resected). 7080869
Miller AR, Addis BJ, Clarke PD. Nitrofurantoin and chronic active hepatitis. Ann Intern Med 1982; 97: 452. (65 year old man developed jaundice 12 months after starting daily nitrofurantoin [bilirubin 3.2 mg/dL, moderate ALT and Alk P elevations, ANA positivity], resolving with prednisone therapy within 4 months of stopping). 7114646
Penn RG, Griffin JP. Adverse reactions to nitrofurantoin in the United Kingdom, Sweden, and Holland. Br Med J (Clin Res Ed) 1982; 284 (6327): 1440-2. (Between 1964 and 1980, the UK drug regulatory authority received 18 reports of liver injury due to nitrofurantoin [1 fatal]; rates were similar to those from Sweden). 6282377
Berry WR, Warren GH, Reichen J. Nitrofurantoin-induced cholestatic hepatitis from cow's milk in a teenaged boy. West J Med 1984; 140: 278-80. (16 year old boy developed rash, fever and jaundice [bilirubin 15.4 mg/dL, ALT 68 U/L, Alk P 3 times ULN] without any drug exposure, except for recently drinking milk from cows who were being treated with parenteral nitrofurantoin). 6730475
Baetens P, Ramboer C. Chronic active hepatitis due to hydroxymethyl-nitrofurantoin in a male patient. Acta Clin Belg 1984; 39: 85-91. (66 year old man developed weight loss and fatigue, 4 years after starting daily nitrofurantoin [bilirubin 0.8 mg/dL, ALT 225 U/L, Alk P 152 U/L, IgG 2343 mg/dL, ANA positive], biopsy showing chronic hepatitis without fibrosis and laboratory abnormalities resolving within 3 months of stopping). 6741394
Young TL, Achkar E, Tuthill R, Ferguson DR. Chronic active hepatitis induced by nitrofurantoin. Cleve Clin Q 1985; 52: 253-6. (2 cases: 71 and 61 year old women developed chronic hepatitis 2 and 5 years after starting daily nitrofurantoin [bilirubin 16.0 and 10.5 mg/dL, AST 1828 and 1200 U/L, Alk P 580 and 400 U/L, ANA 1:320 and 1:160], both improving on stopping, but one requiring corticosteroids). 4028427
Stricker BH, Blok AP, Claas FH, Van Parys GE, Desmet VJl. Hepatic injury associated with the use of nitrofurans: a clinicopathological study of 52 reported cases. Hepatology 1988; 8: 599-606. (Analysis of 52 cases of nitrofurantoin hepatotoxicity reported to a Central Registry in the Netherlands; onset varied from less than a week to several years after starting nitrofurantoin; overall, 59% were jaundiced, 11% had rash and 20% eosinophilia, 45 were fatal, estimated to occur in 1:3000-1:5000 users; separated cases into "acute" vs "chronic" injury, chronic cases more likely to have ANA positivity and hepatocellular pattern of injury). 3371877
Shah RR, Wade G. Reappraisal of the risk/benefit of nitrofurantoin: review of toxicity and efficacy. Adverse Drug React Acute Poisoning Rev 1989; 8: 183-201. (Review of structure, pharmacokinetics, safety and efficacy of nitrofurantoin for urinary tract infections; nitrofurantoin is a nitrated furan 5-member ring with a hydantoin side chain, which is minimally metabolized by the liver and excreted rapidly in the urine). 2694823
Coraggio MJ, Gross TP, Roscelli JD. Nitrofurantoin toxicity in children. Pediatr Infect Dis J 1989; 8: 163-6. (Review of reports of severe adverse reactions to nitrofurantoin in children from literature and FDA reports found 40 reports, 11 had liver injury [2 fatal] yielding estimate of 1 case per million users). 2652087
Kursbaum A, Rottenstreich E. [Acute hepatitis and pneumonitis associated with nitrofurantoin]. Harefuah 1990; 119: 427-8. Hebrew. (65 year old woman developed abdominal pain and cough 2 months after starting nitrofurantoin [AST 378 U/L, bilirubin and Alk P normal, ANA negative], resolving within 4 weeks of stopping). 2074065
Mollison LC, Angus P, Richards M, Jones RMcL, Ireton J. Hepatitis due to nitrofurantoin. Med J Aust 1992; 156: 347-9. (3 women, ages 33, 56 and 62 years, developed jaundice 4 years [2] and 6 weeks after starting daily nitrofurantoin therapy [bilirubin 27.1, 33.0 and 3.5 mg/dL, AST 1045, 839 and 94 U/L, Alk P 101, 247 and 322 U/L, ANA 1:160, 1:2560, and not provided], one had liver transplant, one died and one recovered). 1588868
Paiva LA, Wright PJ, Koff RS. Long-term hepatic memory for hypersensitivity to nitrofurantoin. Am J Gastroenterol 1992; 87: 891-3. (56 year old woman developed fever and jaundice 2.5 weeks after taking 2 doses of nitrofurantoin [bilirubin 11.4 rising to 32.4 mg/dL, ALT 3355 U/L, Alk P 215 U/L, protime 16 sec], and subsequent medical history identified a similar bout of hepatitis [bilirubin 21.8 mg/dL, ALT 470 U/L, Alk P 225 U/L] 3 months after starting nitrofurantoin 17 years earlier). 1615946
Reinhart HH, Reinhart E, Korlipara P, Peleman R. Combined nitrofurantoin toxicity to liver and lung. Gastroenterology 1992; 102 (4 Pt 1): 1396-9. (67 year old woman developed cough, lung infiltrates and then jaundice 2 years after starting daily nitrofurantoin [bilirubin 7.6 rising to 14.6 mg/dL, ALT 1184 U/L, Alk P 203 U/L, ANA 1:640], resolving slowly upon stopping). 1551546
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; nitrofurantoin accounted for 16 cases of liver injury [1.3%], 4 of which were fatal and ranking 4th as a cause of hepatotoxicity). 1506809
Hebert MF, Roberts JP. Endstage liver disease associated with nitrofurantoin requiring liver transplantation. Ann Pharmacother 1993; 27: 1193-4. (40 year old woman developed acute liver failure 4 weeks after starting nitrofurantoin [200 mg twice daily] [bilirubin 25.4 mg/dL, ALT 1182 U/L, Alk P 246 U/L, ANA negative], with progressive stupor and undergoing emergency liver transplantation). 8251685
Mulberg AE, Bell LM. Fatal cholestatic hepatitis and multisystem failure associated with nitrofurantoin. J Pediatr Gastroenterol Nutr 1993; 17: 307-9. (16 year old girl developed erythema multiforme, respiratory failure and jaundice [bilirubin 3.8 mg/dL, ALT 267 U/L, Alk P 610 U/L, GGT 331 U/L, eosinophils 29%], dying of respiratory failure despite improvement in liver injury upon stopping). 8271132
Berson A, Freneaux E, Larrey D, Lepage V, Douay C, Mallet C, Fromenty B, Benhamou JP, Pessayre D. Possible role of HLA in hepatotoxicity. An exploratory study in 71 patients with drug-induced idiosyncratic hepatitis. J Hepatol. 1994; 20: 336-42. (HLA A, B, DR and DQ typing done on 71 patients with hepatotoxicity showed slight increase in A11 [23% vs 12% in controls] mostly with antidepressants [50%] and diclofenac [75%: 3/4], but otherwise without prominent correlations; no cases of nitrofurantoin were tested). 8014443
Westphal JF, Vetter D, Brogard JM. Hepatic side-effects of antibiotics. J Antimicrob Chemother 1994; 33: 387-401. (Review of hepatotoxicity of antibiotics including nitrofurantoin). 8040106
Hautekeete ML. Hepatotoxicity of antibiotics. Acta Gastroenterol Belg 1995; 58: 290-6. (Review of antibiotic hepatotoxicity including nitrofurantoin which can cause both an acute and chronic hepatitis, either hepatocellular or cholestatic, the incidence estimated to be 2 per 10,000 patient years). 7491842
Reddy KR, Schiff ER. Hepatotoxicity of antimicrobial, antifungal, and antiparasitic agents. Gastroenterol Clin North Am. 1995; 24: 923-36. (Review of hepatotoxicity of antimicrobials, nitrofurantoin being mentioned as the prototype example of drug induced chronic hepatitis, arising after 4 weeks to 11 years of therapy, usually in older patients and accompanied by autoantibodies). 8749905
Burgert SJ, Burke JP, Box TD. Reversible nitrofurantoin-induced chronic active hepatitis and hepatic cirrhosis in a patient awaiting liver transplantation. Transplantation 1995; 59: 448-9. (51 year old woman developed jaundice 12 years after starting daily nitrofurantoin [bilirubin 3.8 mg/dL, ALT 470 U/L, Alk P 168 U/L, ANA negative, globulins 5.9 g/dL], which worsened over 6 month period, but then resolved upon stopping and with corticosteroid therapy). 7871583
George DK, Crawford DH. Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf 1996; 15: 79-85. (Review of hepatotoxicity of antibiotics including nitrofurantoin). 8862966
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports over 21 year period in New Zealand identified 943 cases of hepatotoxicity; nitrofurantoin accounted for 12 cases [1.3%] and ranked 20th overall). 8816722
Yalçin S, Sahin A, Yalçin B, Altinok G. Nitrofurantoin toxicity to both liver and lungs. Liver 1997; 17: 166-7. (62 year old woman developed cough and shortness of breath after taking nitrofurantoin daily for 5 years [bilirubin 0.9 mg/dL, ALT 178 U/L, Alk P 77 U/L, globulins 6.3 g/dL, ANA positive], resolving within 2 weeks of stopping). 9249732
Kelly BD, Heneghan MA, Bennani F, Connolly CE, O'Gorman TA. Nitrofurantoin-induced hepatotoxicity mediated by CD8+ T cells. Am J Gastroenterol 1998; 93: 819-21. (75 year old woman developed cough and fatigue 18 months after starting daily nitrofurantoin [bilirubin 0.8 mg/dL, ALT 238 U/L, Alk P 126 U/L], resolving within 6 months of stopping). 9625135
Brumfitt W, Hamilton-Miller JM. Efficacy and safety profile of long-term nitrofurantoin in urinary infections: 18 years' experience. J Antimicrob Chemother 1998; 42: 363-71. (Retrospective analysis of 219 women on long term nitrofurantoin prophylaxis of urinary tract infections, reported no serious adverse events or jaundice; nausea occurred in 46%, but often resolved with continued use or dose adjustment). 9786476
Karmon Y, Edoute Y. [Hepatic injury associated with use of nitrofurantoin]. Harefuah 1999; 136: 406-8. Hebrew. (Review of liver injury of nitrofurantoin). 10914251
Schattner A, Von der Walde J, Kozak N, Sokolovskaya A, Knobler H. Nitrofurantoin-induced immune-mediated lung and liver disease. Am J Med Sci 1999; 317: 336-40. (60 year old woman developed cough and jaundice 3 years after starting daily nitrofurantoin [bilirubin 13.2 rising to 21.0 mg/dL, ALT 467 U/L, Alk P 352 U/L, ANA positive], who died suddenly of sepsis soon thereafter). 10334121
Dam-Larsen S, Kromann-Andersen H. [Hepatic toxicity of nitrofurantoin. Cases reported to the Center for Monitoring Adverse Drug Reactions 1968-1998]. Ugeskr Laeger 1999; 161: 6650-2. Danish. (44 cases of nitrofurantoin hepatotoxicity were reported to a Danish registry between 1968 and 1998; 93% were women, median age 69 years, injury arising after 2 days to 7 years of use, 4 had acute liver failure, 5 had recurrence on reexposure). 10643355
Edoute Y, Karmon Y, Roguin A, Ben-Ami H. Fatal liver necrosis associated with the use of nitrofurantoin. Isr Med Assoc J 2001; 3: 382-3. (73 year old woman developed jaundice 14 months after starting daily nitrofurantoin [bilirubin 14.5 mg/dL, ALT 884 U/L, Alk P 190 U/L, ANA positive], treated with corticosteroids, but developed hepatic failure, ascites, renal failure and died 13 days after admission). 11411208
Amit G, Cohen P, Ackerman Z. Nitrofurantoin-induced chronic active hepatitis. Isr Med Assoc J 2002; 4: 184-6. (3 women, ages 64 to 76 years developed jaundice 1-5 years after starting nitrofurantoin [bilirubin 14.7, 15.3 and 2.2 mg/dL, ALT 1700, 515 and 850 U/L, Alk P 300, 390 and 110 U/L, all ANA positive], all treated with corticosteroids, 1 died). 11908259
Liu ZX, Kaplowitz N. Immune-mediated drug-induced liver disease. Clin Liver Dis 2002; 6: 755-74. (Review of role of immune system in drug induced liver disease; nitrofurantoin mentioned, but not specifically discussed). 12362579
Thiim M, Friedman LS. Hepatotoxicity of antibiotics and antifungals. Clin Liver Dis 2003; 7: 381-99, vi-vii. (Review of hepatotoxicity of antimicrobials including nitrofurantoin). 12879990
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 7 of which [5%] were attributed to nitrofurantoin, ranking 6th in frequency). 15390328
Karpman E, Kurzrock EA. Adverse reactions of nitrofurantoin, trimethoprim and sulfamethoxazole in children. J Urol 2004; 172: 448-53. (Review of side effects of nitrofurantoin in children, including cutaneous, gastrointestinal, hematologic, neurologic, pulmonary and liver adverse events; hepatic side effects are the most lethal complications, with 20 cases reported in children, 3 fatal). 15247700
Linnebur SA, Parnes BL. Pulmonary and hepatic toxicity due to nitrofurantoin and fluconazole treatment. Ann Pharmacother. 2004; 38: 612-6. (73 year old man developed cough, shortness of breath and pulmonary infiltrates and found to have ALT elevations [223 U/L], with normal bilirubin 5 years after starting nitrofurantoin and 2 months after starting fluconazole, resolving within 4 weeks of stopping both medications). 14966256
Galan MV, Potts JA, Silverman AL, Gordon SC. The burden of acute nonfulminant drug-induced hepatitis in a United States tertiary referral center. J Clin Gastroenterol 2005; 39: 64-7. (Between 1993 and 2002, 96 patients were evaluated for acute liver disease at a single referral center; 32 were attributed to a medication among whom 44% were women, mean age 42 [range 16-80] years, and 3 were due to nitrofurantoin [10%], making it 4th in frequency). 15599214
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease, nitrofurantoin was not listed in the top 20 agents implicated [those with at least 5 cases]). 16083708
Salle V, Lafon B, Smail A, Cévallos R, Chatelain D, Andréjak M, Ducroix JP. [Nitrofurantoin-induced lupus-like syndrome associated with hepatitis]. Rev Med Interne 2006; 27: 344-6. (71 year old woman developed polyarthralgias and liver test abnormalities after 4 years of therapy with nitrofurantoin [bilirubin not given, ALT 263 U/L, Alk P 310 U/L, GGT 801 U/L, ANA 1:2560], improving rapidly upon withdrawal and with prednisone therapy). 16364504
Boelsterli UA, Ho HK, Zhou S, Leow KY. Bioactivation and hepatotoxicity of nitroaromatic drugs. Curr Drug Metab. 2006; 7: 715-27. (Review of metabolism and hepatic toxicity of nitroaromatic drugs, including nitrofurantoin which causes oxidative stress within hepatocytes which can deplete glutathione, produce oxidative free radicals, disrupt calcium homeostasis and increase labile iron pools). 17073576
Koulaouzidis A, Bhat S, Moschos J, Tan C, De Ramon A. Nitrofurantoin-induced lung- and hepatotoxicity. Ann Hepatol 2007; 6: 119-21. (57 year old woman developed cough, pulmonary infiltrates and abnormal liver tests 16 months after starting nitrofurantoin [bilirubin 0.5 mg/dL, ALT 424 U/L, Alk P 282 U/L, ANA negative], resolving within 4 months of stopping). 17519837
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, nitrofurantoin was implicated in 14 cases and ranked second only to amoxicillin/clavulanate as a cause of liver injury). 18955056
Aksamija A, Horvat G, Habek D, Zalac D, Jendris E. Nitrofurantoin-induced acute liver damage in pregnancy. Arh Hig Rada Toksikol 2009; 60: 357-61. (31 year old woman in her 36th week of gestation was found to have serum enzyme elevations 2 weeks after starting nitrofurantoin [bilirubin 1.2 mg/dL, ALT 940 U/L, Alk P 273 U/L] at the time of induced delivery, which resolved rapidly upon stopping the medication). 19789166
Beigel R, Perets R, Mouallem M. Acute kidney injury, hepatitis, and CPK elevation associated with nitrofurantoin therapy. Am J Med Sci 2009; 337: 132-3. (57 year old woman developed fever within a day of starting nitrofurantoin and was found to have serum enzyme elevations when it was stopped after 5 days [bilirubin 1.1 mg/dL, ALT 192 U/L, Alk P 183 U/L, 11.7% eosinophils], resolving rapidly). 19214031
Cetti RJ, Venn S, Woodhouse CR. The risks of long-term nitrofurantoin prophylaxis in patients with recurrent urinary tract infection: a recent medico-legal case. BJU Int 2009; 103: 567-9. (Woman who developed pulmonary and hepatic complications after 2.5 years of nitrofurantoin therapy successfully sued her physicians for failing to follow recommendations of the British National Formulary). 18782308
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 12 were attributed to nitrofurantoin which ranked in the top 3 most common single causes). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to nitrofurantoin]. 20648003
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, et al. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Retrospective analysis of 261 cases of autoimmune hepatitis, 24 [9%] of which were due to a medication; 11 nitrofurantoin and 11 minocycline; drug induced cases resembled idiopathic cases in all regards, except that all patients were able to stop corticosteroids without relapse). 20512992
Appleyard S, Saraswati R, Gorard DA. Autoimmune hepatitis triggered by nitrofurantoin: a case series. J Med Case Rep 2010; 4: 311. (Three women, ages 65, 42 and 74 years developed liver injury 2-6 years after starting nitrofurantoin [bilirubin 37.9, normal and 23 mg/dL, ALT 1322, 469 and 1423 U/L, Alk P 227, normal and 207 U/L, ANA 1:320 to 1: 640], all survived, but required corticosteroid therapy for extended periods). 20863377
Ozaslan E. Drug-induced autoimmune hepatitis: an easily reversible type of liver fibrosis? Hepatology. 2011; 53: 370. (Letter in response to Björnsson [2010] discussing the reversibility of early fibrosis in cases of drug induced autoimmune hepatitis). 20848612
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76. (Review of drug induced autoimmune hepatitis, the principal causes being minocycline and nitrofurantoin; other causes being methyldopa, hydralazine, statins, fibrates, diclofenac, anti-TNF agents, interferons, propylthiouracil and isoniazid). 21327704
Sugimoto K, Ito T, Yamamoto N, Shiraki K. Seven cases of autoimmune hepatitis that developed after drug-induced liver injury. Hepatology 2011; 54: 1892-3. (Letter describing 7 patients, one man and 6 women, ages 20 to 68 years, with autoimmune hepatitis attributed to medications, but with relapsing course despite stopping medications which included ofloxacin, a cephalosporin, benzbromarone, NSAIDs and herbals). 21725992
Milić R, Plavec G, Tufegdzić I, Tomić I, Sarac S, Loncarević O. Nitrofurantoin-induced immune-mediated lung and liver disease. Vojnosanit Pregl 2012 Jun; 69 (6): 536-40. (55 year old woman developed lung and liver injury after long term use of nitrofurantoin, resolving with stopping therapy and corticosteroids). 22779302
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144 (7): 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 4 attributed to nitrofurantoin [ranking 3rd] for an estimated incidence of 1 per 1369 persons exposed). 23419359
Sakaan SA, Twilla JD, Usery JB, Winton JC, Self TH. Nitrofurantoin-induced hepatotoxicity: a rare yet serious complication. South Med J 2014; 107: 107-13. (Review of the incidence, epidemiology, pathogenesis, clinical features, course and outcome, and management of nitrofurantoin induced liver injury). 24926677
deLemos AS, Foureau DM, Jacobs C, Ahrens W, Russo MW, Bonkovsky HL. Drug-induced liver injury with autoimmune features. Semin Liver Dis 2014; 34: 194-204. (Review of drug induced liver injury with autoimmune features including examples, one due to nitrofurantoin). 24879983
Hydes T, Wright M, Jaynes E, Nash K. Nitrofurantoin immune-mediated drug-induced liver injury: a serious complication of a commonly prescribed medication. BMJ Case Rep 2014; 2014. pii: bcr2013203136. (2 women, ages 50 and 75, developed jaundice 12 months after starting chronic therapy with nitrofurantoin, both with ALT elevations known for 6 months [bilirubin 7.7 and 7.6 mg/dL, ALT 747 and 868 U/L, Alk P 294 and 132 U/L, INR normal and 1.5, ANA negative but IgG elevated in both], both improving rapidly with stopping nitrofurantoin and starting prednisone). 24599428
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 17 were attributed to nitrofurantoin [9.6%], ranking third). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 42 cases [5.8%] were attributed to nitrofurantoin, ranking third; mean age 64 years, all women, 62% hepatocellular, 52% ANA positive, mean initial ALT 932 U/L, Alk P 278 U/L, bilirubin 8.7 mg/dL, 9% fatal, 24% with evidence of chronic injury in follow up). 25754159
Yeong TT, Lim KH, Goubet S, Parnell N, Verma S. Natural history and outcomes in drug-induced autoimmune hepatitis. Hepatol Res 2016; 46: E79-88. (Among 82 patients with autoimmune hepatitis, 11 were due to medication [nitrofurantoin 4, statins 4, herbal products in 2 and diclofenac in 2], clinical features were similar but those due to medications rarely relapsed on stopping and none died or required liver transplant). 25943838
Stine JG, Northup PG. Autoimmune-like drug-induced liver injury: a review and update for the clinician. Expert Opin Drug Metab Toxicol 2016; 12: 1291-301. (Review of drug induced liver injury with autoimmune features). 27402321
Claussen K, Stocks E, Bhat D, Fish J, Rubin CD. How common are pulmonary and hepatic adverse effects in older adults prescribed nitrofurantoin? J Am Geriatr Soc 2017; 65: 1316-20. (Among 3400 patients 65 years or older prescribed nitrofurantoin over a 7 year period, electronic medical records identified 641 with a possible adverse event, but on review of charts most were considered unrelated and only one case of hepatotoxicity was considered possibly related). 28306135
Björnsson ES. Drug-induced liver injury due to antibiotics. Scand J Gastroenterol 2017; 52: 617-23. (Review of the hepatotoxicity of antibiotics which are the single major drug class implicated in liver injury and nitrofurantoin often ranking among the top 3 antimicrobials, the estimated frequency being ~1:1500 users, cases usually having hepatocellular pattern of injury often with autoimmune features). 28276834
Prieto de Paula JM, Martín-Luquero Ibáñez M, Franco Hidalgo S. Nitrofurantoin and non-autoimmune hepatitis. Med Clin (Barc) 2017; 148: 382-3. (47 year old woman with recurrent cystitis developed jaundice and abdominal pain 3 months after starting nitrofurantoin [bilirubin 6.4 mg/dL, ALT 1680 U/L, Alk P 220 U/L, SMA 1:40, ANA negative], resolving within 45 days of stopping). 28238334
de Boer YS, Kosinski AS, Urban TJ, Zhao Z, Long N, Chalasani N, Kleiner DE, et al.; Drug-Induced Liver Injury Network. Features of autoimmune hepatitis in patients with drug-induced liver injury. Clin Gastroenterol Hepatol 2017; 15: 103-112.e2. (Among 42 cases of nitrofurantoin induced liver injury, all were women, median age 65 years, latency less than 1 week in 5 and greater than 1 year in 26 cases, initial median ALT 739 U/L, Alk P 190 U/L, bilirubin 4.7 mg/dL, with autoimmune features in 83%, severe course in 30%, fatal in 2 and liver transplant in 3; ANA levels declined during follow up after stopping drug). 27311619
Ramadas P, Krishnan P, Frechette V. An unusual case of nitrofurantoin-associated hepatotoxicity. Am J Ther 2018; 25: e378-e379. (79 year old woman with recurrent cystitis on nitrofurantoin for 6 years developed fatigue and anorexia [bilirubin 2.8 mg/dL, ALT 246 U/L, Alk P 275 U/L, ANA positive], with cirrhosis and splenomegaly on CT scan and improvement on stopping drug with normal liver enzymes 3 months later). 28207423
Martínez-Casas OY, Díaz-Ramírez GS, Marín-Zuluaga JI, Muñoz-Maya O, Santos O, Donado-Gómez JH, Restrepo-Gutiérrez JC. Differential characteristics in drug-induced autoimmune hepatitis. JGH Open 2018; 2: 97-104. (Among 190 patients diagnosed with autoimmune hepatitis over a 7 year period, 12 were considered drug induced from nitrofurantoin [n=8], diclofenac [n=2], adalimumab [1] or propylthiouracil [1], but were similar in age, gender and autoantibody status to spontaneous autoimmune hepatitis, differing by ability to stop corticosteroids [92% vs 23%], and absence of cirrhosis and liver transplantation and death which occurred in 13%, 6% and 3% of spontaneous cases). 30483571
Kapral N, Saxena R, Sule AA, Markle B. Nitrofurantoin: friend or foe? BMJ Case Rep 2018; 2018. pii: bcr-2018-225629. (69 year old man developed jaundice within 5 days of starting nitrofurantoin for cystitis [bilirubin 12.4 mg/dL, ALT 608 U/L, Alk P 2640 U/L, INR 1.35], improving on stopping and with corticosteroid therapy). 30115718
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. Epidemiology of drug-induced liver injury in a university hospital from Colombia: updated RUCAM being used for prospective causality assessment. Ann Hepatol 2019; 18: 501-7. (Among 18 cases of drug induced liver injury seen at a University hospital in Colombia during a 1 year period [2015-16], 10 [56%] were attributed to antimicrobial agents including 1 due to nitrofurantoin). 31053545
Benyamine A, Granel B, Belenotti P, Masson E, Default A, Garcia S, Serratrice J, et al. Severe nitrofurantoin-induced adverse drug reactions: is there a benefit of sequential therapy? Therapie 2019; 74: 553-6. (72 year old woman developed pneumonitis and abnormal liver tests 6 months after starting nitrofurantoin [bilirubin 0.8 mg/dL, ALT 362 U/L, Alk P 99 U/L], biopsy showing chronic hepatitis, resolving within 40 days of stopping). 31027709
Speirs TP, Tuffin N, Mundy-Baird F, Sakota H, Mulholland S, Westlake M, Lyon M, et al. Long-term nitrofurantoin: an analysis of complication awareness, monitoring, and pulmonary injury cases. BJGP Open. 2021;5:BJGPO.2021.0083. PMID: 34407964. (Survey of 125 UK prescribers [mostly general practitioners) of long-term nitrofurantoin, 42% were unaware of its risk of liver injury and 41% never monitored liver tests).
Wonnacott S, Gala D, Shah M, Kaul D, Kumar V. An unusual case of drug-induced liver injury secondary to nitrofurantoin use. Cureus. 2022;14:e26882.. (24 year old woman developed epigastric pain within 3 days of starting nitrofurantoin [bilirubin 1.9 mg/dL, ALT 476 U/L, Alk P 120 U/L, INR 1.0), with rapid improvement in symptoms upon stopping, but only 2 days of follow up of the liver abnormalities). 35978742
Weber S, Gerbes AL. Relapse and need for extended immunosuppression: novel features of drug-induced autoimmune hepatitis. Digestion. 2023;104:243-248.. (Comparison of 19 cases of autoimmune hepatitis to 11 cases of drug-induced autoimmune like hepatitis found a more rapid decline in ALT levels with corticosteroid therapy and a lower rate of relapse upon stopping [36%] in the drug-related cases). 36603570
Chalasani N, Li YJ, Dellinger A, Navarro V, Bonkovsky H, Fontana RJ, Gu J, et al; Drug Induced Liver Injury Network. Clinical features, outcomes, and HLA risk factors associated with nitrofurantoin-induced liver injury. J Hepatol. 2023;78:293-300.. (Among 78 cases of drug-induced liver injury attributed to nitrofurantoin enrolled in the US Drug Induced Liver Injury Network between 2004 and 2021, all but one were women and the latency to onset varied greatly, from short [7 days or less:n=18,] intermediate [8 to 364 days:n=16], to long [365 or more days:n=44], the longer [vs short and intermediate] cases being more severe [36% vs 11% and 31%], more likely to have autoantibodies [90% vs 44% and 50%], to be treated with corticosteroids [61% vs 27% and 44%], to have levels of AST greater than ALT [73% vs 33% and 50%], to have biopsy findings of chronic hepatitis or cirrhosis, and to be associated with HLA-DRB1*11:04). 36152763
Daly AK, Bjornsson ES, Lucena MI, Andrade RJ, Aithal GP. Drug-induced liver injury due to nitrofurantoin: similar clinical features, but different HLA risk alleles in an independent cohort. J Hepatol. 2023;78:e165-e166.. (Letter in response to Chalasani et al [2022] describing a multinational non-US cohort of 26 cases of nitrofurantoin induced liver injury that had similar clinical features to the US study, but with no cases harboring HLA-DRB1*11:04, instead having a significant association with HLA-A*33:01 [AF and numbers not provided]). 36460164
Bessone F, Ferrari A, Hernandez N, Mendizabal M, Ridruejo E, Zerega A, Tanno F, et al. Nitrofurantoin-induced liver injury: long-term follow-up in two prospective DILI registries. Arch Toxicol. 2023;97:593-602.. (Among 23 cases of nitrofurantoin induced liver injury enrolled in the Spanish [n=3] and Latin American {n=20] drug induced liver injury networks, the mean age was 61 years, 96% were women, 91% used as prophylaxis for recurrent cystitis, 48% had latency above 6 months, 83% hepatocellular injury, 48% jaundice, 65% autoantibodies, 22% autoimmune like hepatitis, only 4% were severe and none fatal). 36416910
García-Cortés M, Ortega-Alonso A, Matilla-Cabello G, Medina-Cáliz I, Castiella A, Conde I, Bonilla-Toyos E, et al. Clinical presentation, causative drugs and outcome of patients with autoimmune features in two prospective DILI registries. Liver Int. 2023;43:1749-1760.. (Among 1426 cases of drug-induced liver injury enrolled in a Spanish and a Latin American registry 33 were assessed as having an autoimmune like clinical presentation, the most common causes being nitrofurantoin [n=5], minocycline [4] and fluvastatin [4]). 37269163
Dhingra M, Ghosh A. Drug-induced liver injury following prolonged use of nitrofurantoin. Ann Afr Med. 2024;23:514-517.. (62 year old Indian woman developed abdominal pain and jaundice more than 2 years after starting nitrofurantoin for recurrent cystitis [bilirubin 4.2 mg/dL, ALT 1173 U/L, Alk P 434 U/L, INR 1.3] with slow improvement on stopping, and normal tests 5 months later). 39034584
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including nitrofurantoin which was estimated to arise at a rate of 1 per 4,300 patients exposed). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 20 [4.3%] were attributed to nitrofurantoin [95% women, mean age 59 years, 80% hepatocellular, none fatal]). 38992407
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1.. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug-induced liver injury including 5 attributed to nitrofurantoin which was estimated to be 1 per 3,000 persons treated). 39447947
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 53 cases due to nitrofurantoin which was estimated as an incidence of 1 per 2,400 new persons treated each year). 39317916

## OTHER REFERENCE LINKS

1. Recent References on Nitrofurantoin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nitrofurantoin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222007/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))

2. Trials on Nitrofurantoin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nitrofurantoin)